# Nintedanib

## OVERVIEW

### Introduction

Nintedanib is an orally available tyrosine kinase receptor antagonist that inhibits collagen formation and is used to treat idiopathic pulmonary fibrosis. Elevations in serum enzyme levels during nintedanib therapy are not uncommon and multiple instances of acute liver injury with symptoms and jaundice have been reported since its approval and more widescale use.

### Background

Nintedanib (nin ted' a nib) is a small molecular weight tyrosine kinase receptor inhibitor that has potent activity against several growth factor receptors, including vascular endothelial growth factor receptor (VEGFR), fibroblast growth factor receptor (FGFR), and platelet derived growth factor receptor (PDGFR). The inhibition of these receptors causes modulation of many intracellular pathways including inhibition of activities of pro-fibrotic mediators such as transforming growth factor-beta (TGF-β), and decrease in synthesis of extracellular matrix proteins including collagen and fibronectin. Nintedanib has been evaluated as therapy for many different forms of fibrotic lung diseases as well as several forms of cancer. In several large clinical trials, therapy with nintedanib was associated with a decrease in the progressive decline in lung function in patients with idiopathic pulmonary fibrosis, as well as with a decrease in symptomatic, acute pulmonary exacerbations. On the basis of these studies, nintedanib was approved for use in idiopathic pulmonary fibrosis in the United States in 2014 and subsequently for other chronic fibrotic lung diseases such as systemic sclerosis associated lung disease and other chronic fibrosing interstitial lung diseases. However, it has not been approved for use in cancer. Nintedanib is available as capsules of 100 and 150 mg generically and under the brand name OFEV. The typical initial dose in adults is 150 mg orally twice daily. Temporary or permanent dose reduction is advised for management of adverse reactions or poor tolerability. Side effects are common and include diarrhea, nausea, dyspepsia, abdominal pain, decreased appetite, headache and fatigue. Rare, but potentially severe adverse events include excessive bleeding, poor wound healing, gastrointestinal perforation, liver injury, embryo-fetal toxicity, and arterial thrombotic events.

### Hepatotoxicity

In large preregistration randomized controlled trials, serum enzyme elevations occurred in 8% to 16% of patients receiving nintedanib compared to 3% of controls. Aminotransferase values above 3 times the upper limit of normal (ULN) occurred in only 3% to 5% of patients (compared to <1% of controls), and discontinuation of therapy because of ALT elevations was required in less than 1% of nintedanib treated subjects. The enzyme elevations during nintedanib therapy were generally not accompanied by symptoms of liver injury or jaundice and resolved even without dose modification in many subjects. Subsequent to the approval of nintedanib as therapy for fibrotic pulmonary diseases, several reports of clinically apparent liver injury attributable to its use were published from Asia, Europe, and the United States. In reported cases, the latency to onset ranged for 4 to 24 months and the pattern of enzyme elevations ranged from cholestatic to hepatocellular. Fatal cases have been reported to the sponsor and to the FDA, but details of the liver injury were not well defined and the causality was often only possible or at most probable. Analysis of rates of ALT and AST elevations during nintedanib therapy have been reported to be as high as 68%, but usually self-limited and not accompanied by jaundice. Injury appears to be more frequent in the elderly, in Asians, and in patients with lower body weight and body surface area. Starting treatment at 100 mg twice daily and dose reduction to 100 mg twice daily appears to be associated with lower rates of aminotransferase elevations.

These reports, however, led to revisions of the product label that now include warnings of liver injury that could be severe and even fatal. Warnings were also added to use caution in treating patients with concurrent known liver disease. Monitoring of liver tests are recommended by expert panels at baseline and at least monthly for the first 3 months and every 3 months thereafter. Thus, nintedanib is likely to cause clinically apparent liver injury, and careful monitoring and early discontinuation (as was done in the preregistration studies) may prevent its occurrence.

Likelihood score: C (probable cause of clinically apparent liver injury that can be severe and even fatal).

### Mechanism of Injury

The mechanism by which nintedanib might cause liver injury is not known. It is metabolized in the liver largely via the cytochrome P450 system and idiosyncratic liver injury may be due to its metabolism to a toxic or immunogenic intermediate. Comparison of clinical features of patients with and without hepatic injury during nintedanib therapy suggests that hepatic enzyme elevations are more frequent in patients with a low body weight and body surface area suggesting that pharmacokinetic features may underlie risk for injury, which would explain the higher rates in the elderly and in Asians. Nintedanib is also susceptible to drug-drug interactions with strong inducers or inhibitors of CYP 3A4.

### Outcome and Management

While chronic therapy with nintedanib can be associated with transient mild-to-moderate serum aminotransferase elevations, it can also result in clinically apparent liver injury. Current recommendations are for monitoring of serum aminotransferase, alkaline phosphatase and bilirubin levels monthly during the first 3 months and every 3 months thereafter as needed. Patients who develop aminotransferase elevations on therapy should be monitored more carefully and considered for dose reduction to 100 mg twice daily with close follow up. Nintedanib therapy should be discontinued if jaundice or symptoms of liver injury arise or if serum ALT or AST levels rise above 5 times the ULN.

Drug Class: Pulmonary Fibrosis Agents

Other Drugs in the Class: Pirfenidone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Nintedanib – OFEV®

DRUG CLASS

Pulmonary Fibrosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Nintedanib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Nintedanib | 656247-17-5 | C31-H33-N5-O4 | SID: 135267499

## ANNOTATED BIBLIOGRAPHY

References updated: 12 December 2023

Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. (Multi-authored textbook of hepatotoxicity published in 2013; does not discuss nintedanib).
Rockey DC. Current and future anti-fibrotic therapies for chronic liver disease. Clin Liver Dis 2008; 12: 939-62. (Review of the pathogenesis and cellular pathways of fibrosis in patients with chronic liver disease and status of antifibrotic agents, none of which have been shown to be effective in treating or preventing hepatic fibrosis). 18984475
Richeldi L, Costabel U, Selman M, Kim DS, Hansell DM, Nicholson AG, Brown KK, et al. Efficacy of a tyrosine kinase inhibitor in idiopathic pulmonary fibrosis. N Engl J Med 2011; 365: 1079-87. (Among 1066 patients with idiopathic pulmonary fibrosis enrolled in two studies of nintedanib [150 mg twice daily] versus placebo, the decline in forced vital capacity was less with nintedanib, but adverse events were more frequent and ALT or AST elevations above 3 times ULN occurred in 4.9-5.2% vs <1% on placebo, although no patient developed clinically apparent liver injury with jaundice). 21992121
Two new drugs for idiopathic pulmonary fibrosis. Med Lett Drugs Ther 2014; 56 (1457): 123-4. (Concise review of the mechanism of action, efficacy and safety of pirfenidone and nintedanib for idiopathic pulmonary fibrosis mentions that both agents can increase hepatic enzyme levels and dose adjustment may be required). 25461229
Richeldi L, du Bois RM, Raghu G, Azuma A, Brown KK, Costabel U, Cottin V, et al.; INPULSIS Trial Investigators. Efficacy and safety of nintedanib in idiopathic pulmonary fibrosis. N Engl J Med 2014; 370: 2071-82. (Among 432 patients with idiopathic pulmonary fibrosis treated with 1 of 4 doses of nintedanib or placebo for 1 year, decline in vital capacity and number of pulmonary exacerbations were less in the 86 patients who received the highest dose [150 mg twice daily], but dermatologic and gastrointestinal side effects were more frequent, as were ALT or AST elevations above 3 times ULN [6 patients, 7.1%, vs none with placebo], but no clinically apparent liver injury was reported). 24836310
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to agents for pulmonary fibrosis). 25754159
Keating GM. Nintedanib: a review of its use in patients with idiopathic pulmonary fibrosis. Drugs 2015; 75: 1131-40. (Review of the mechanism of action, pharmacology, efficacy and safety of nintedanib as therapy of idiopathic pulmonary fibrosis states that serum enzyme elevations during therapy "were reversible and were not associated with clinical manifestations of liver injury"). 26063212
Abdel-Rahman O, Bahie Eldin N, ElHalawani H. Risk of selected gastrointestinal and hepatic toxicities in cancer patients treated with nintedanib: a meta-analysis. Future Oncol 2016; 12: 2163-72. (Meta-analysis of nine controlled trials of nintedanib in various forms of cancer found, rates of ALT elevations above 5 times ULN in 9.2% of 2029 nintedanib treated vs 2.7% of 1543 controls). 27301454
Kim Y, Lee SJ, Lee JY, Lee SH, Sun JM, Park K, An HJ, et al. Clinical trial of nintedanib in patients with recurrent or metastatic salivary gland cancer of the head and neck: A multicenter phase 2 study (Korean Cancer Study Group HN14-01). Cancer 2017; 123: 1958-64. (Among 20 subjects with metastatic salivary gland cancer treated with nintedanib [200 mg twice daily], there were no objective responses, and adverse events including ALT elevations in 30% which were above 5 times ULN in 10%; no mention of clinically apparent liver injury). 28102887
Olin JL, Woods JA, Garner SJ. Delayed presentation of hepatocellular liver injury after nintedanib administration. Am J Ther 2017; 24: e107-e108. (86 year old man developed fatigue 8 months after starting nintedanib [bilirubin normal, ALT ~410 U/L, Alk P normal], ALT levels having been normal before and for the first 7 months of treatment and returning to near normal rapidly after stopping). 27574930
Ikeda S, Sekine A, Baba T, Yamakawa H, Morita M, Kitamura H, Ogura T. Hepatotoxicity of nintedanib in patients with idiopathic pulmonary fibrosis: A single-center experience. Respir Investig 2017; 55: 51-4. (Among 32 patients with idiopathic pulmonary fibrosis treated with nintedanib at a single Japanese referral center, 59% developed ALT elevations which were above 3 times ULN in 6%, arising usually during the first week and resolving with dose interruption or reduction; no patient developed clinically apparent liver injury or jaundice). 28012494
Marzin K, Kretschmar G, Luedtke D, Kraemer S, Kuelzer R, Schlenker-Herceg R, Schmid U, et al. Pharmacokinetics of nintedanib in subjects with hepatic impairment. J Clin Pharmacol. 2018;58(3):357-363. (Single dose pharmacokinetic studies of nintedanib [100 mg] demonstrated an increase in exposure in patients with Child's A [2-fold] and B [8-fold] cirrhosis compared to healthy controls). 29106740
Ikeda S, Sekine A, Baba T, Yamanaka Y, Sadoyama S, Yamakawa H, Oda T, et al. Low body surface area predicts hepatotoxicity of nintedanib in patients with idiopathic pulmonary fibrosis. Sci Rep. 2017;7:10811. (Among 68 patients with idiopathic pulmonary fibrosis treated with nintedanib [150 mg twice daily] at a single Japanese referral center over a 1 year period, 46 [68%] developed ALT or AST elevations, which were above 3 times ULN in 16 [24%] and above 5 times ULN in 6 [9%], resolving in all patients upon stopping, and recurring in only 4 of 10 who restarted treatment at a lower dose; no mention of bilirubin elevations but 3 patients had mild epigastric pain; patients who developed enzyme elevations had a lower body surface area than those who did not, but similar body mass index). 28883482
Bendstrup E, Wuyts W, Alfaro T, Chaudhuri N, Cornelissen R, Kreuter M, Melgaard Nielsen K, et al. Nintedanib in idiopathic pulmonary fibrosis: practical management recommendations for potential adverse events. Respiration 2019;97:173-184. (Review of the adverse events associated with nintedanib therapy and expert recommendations on their detection, diagnosis and management, mentions that 8-16% of treated patients develop liver test abnormalities with values above 3 times ULN in 5%, usually arising within the first 3 months of treatment and resolving spontaneously or which dose adjustments [~80%]; the authors recommend monitoring before and monthly during the first 6 months of treatment and every 3 months thereafter). 30544129
Lancaster L, Crestani B, Hernandez P, Inoue Y, Wachtlin D, Loaiza L, Quaresma M, et al. Safety and survival data in patients with idiopathic pulmonary fibrosis treated with nintedanib: pooled data from six clinical trials. BMJ Open Respir Res. 2019;6:e000397. (Among 1126 patients with idiopathic pulmonary fibrosis treated with nintedanib [150 mg twice daily] for a mean of 28 months vs 565 treated with placebo for 11 months in controlled trials, adverse events included hepatic enzyme elevations at event rates of 12.1 vs 3.4 per 100 patient-years; no mention of clinically apparent liver injury). 31179001
Distler O, Highland KB, Gahlemann M, Azuma A, Fischer A, Mayes MD, Raghu G, et al.; SENSCIS Trial Investigators. Nintedanib for systemic sclerosis-associated interstitial lung disease. N Engl J Med. 2019;380:2518-2528. (Among 576 patients with idiopathic lung disease associated with systemic sclerosis treated with nintedanib [150 mg twice daily], the annual rate of change of forced vital capacity was -52 vs -93 mL, while total adverse events rates were similar [98% vs 96%], and while severe adverse events were more frequent with nintedanib [18% vs 12.5%] as were ALT or AST elevations of ≥3 times ULN [5% vs 0.7%], but none were associated with jaundice). 31112379
Flaherty KR, Wells AU, Cottin V, Devaraj A, Walsh SLF, Inoue Y, Richeldi L, et al.; INBUILD Trial Investigators. Nintedanib in progressive fibrosing interstitial lung diseases. N Engl J Med. 2019;381:1718-1727. (Among 663 patients with progressive fibrosing interstitial lung disease treated with nintedanib vs placebo, decline in pulmonary function was less with nintedanib [forced vital capacity -81 mL vs -188 mL per year], and overall rates of total adverse events [96% vs 89%] and severe adverse events [18% vs 22%] were similar in both groups, although total discontinuations for side effects were greater with nintedanib [20% vs 10%] as were ALT elevations ≥3 times ULN [13% vs 2%], while ALT elevations accompanied by jaundice occurred in 1 patient in both groups). 31566307
Lasky JA, Criner GJ, Lazarus HM, Kohlbrenner V, Bender S, Richeldi L. Safety of nintedanib in patients with idiopathic pulmonary fibrosis: global pharmacovigilance data. Adv Ther. 2020;37:4209-4219. (Analysis of a global pharmacovigilance database held by Boehringer Ingelheim had data on adverse events based upon 60,107 patient-years of treatment with nintedanib showed rates of hepatic enzyme elevations of 3.1 per 100 patient-years [/100 p-y], diarrhea in 30.2/100 p-y, bleeding in 3.7/100 p-y, and major cardiovascular events in 1.4/100 p-y). 32767182
Schmid U, Weber B, Sarr C, Freiwald M. Exposure-safety analyses of nintedanib in patients with chronic fibrosing interstitial lung disease. BMC Pulm Med. 2021;21:244. (Measurement of plasma levels of nintedanib in treated patients demonstrated a positive relationship between plasma levels and occurrence of diarrhea and aminotransferase elevations as well as higher levels in women than men). 34289823
Librero Jiménez M, Heredia Carrasco C, Fernández Cano MDC. Severe hepatotoxicity secondary to nintedanib. Rev Esp Enferm Dig. 2022;114:244-245. (88 year old man with idiopathic pulmonary fibrosis developed weakness, pruritus and jaundice 2 years after starting nintedanib [bilirubin 3.7 mg/dL , ALT 32 U/L, Alk P 726 U/L, INR 1.3], with improvement but not complete resolution one month after stopping but no further follow up). 33371696
Jena A, Aggarwal T, Mitra S, Singh AK. Nintedanib-induced liver injury: not every liver injury is virus or vaccine-induced in the era of COVID-19. Liver Int. 2022;42:1210-1211. (70 year old man developed jaundice a week after a first dose of COVID-19 vaccine [BBV152: Covaxin] and 4.5 months after starting nintedanib for pulmonary fibrosis after COVID-19 infection [bilirubin 16.1 mg/dL, ALT 61 U/L, Alk P 181 U/L, INR 1.2], which resolved within 3 months of stopping nintedanib). 35195327
Raschi E, Fusaroli M, Gatti M, Caraceni P, Poluzzi E, De Ponti F. Liver injury with nintedanib: a pharmacovigilance-pharmacokinetic appraisal. Pharmaceuticals (Basel). 2022;15:645. (Analysis of spontaneous adverse event reports related to nintedanib made to the FDA’s Adverse Event Reporting System identified 13,249 reports including 91 [0.7%] cases of liver injury 44% from Asia, most frequently in men, median age 68 years, leading to death in 26% and two positive rechallenges, the time to onset averaged 13.5 days). 35631471
Barešić M, Novak S, Perković D, Karanović B, Mirić F, Radić M, Anić B. Real world experience with nintedanib in connective tissue disease-related interstitial lung disease: a retrospective cohort study. Clin Rheumatol. 2023;42:2897-2903. (Among 25 patients with chronic fibrosing lung disease treated with nintedanib in three referral centers in Croatia, adverse events were reported by 16 [64%], diarrhea in 15 [60%], and abnormal liver tests in 1 [4%]). 37393200

## OTHER REFERENCE LINKS

Recent References on Nintedanib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Nintedanib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Nintedanib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Nintedanib)